# Nilotinib

## OVERVIEW

### Introduction

Nilotinib is a selective tyrosine kinase receptor inhibitor used in the therapy of chronic myelogenous leukemia. Nilotinib therapy is associated with transient elevations in serum aminotransferase levels and rare instances of clinically apparent acute liver injury.

### Background

Nilotinib (nye loe' ti nib) is a selective inhibitor of the abnormal tyrosine kinase receptor known as BCR-ABL, formed by the reciprocal translocation between chromosome 9 and 22, which creates the Philadelphia chromosome that is associated with chronic myelogenous leukemia (CML). The BCR-ABL tyrosine kinase receptor is constitutively expressed in leukemic cells and causes unregulated cell growth and proliferation. Nilotinib is a specific inhibitor of BCR-ABL and structurally related to imatinib. Like imatinib, nilotinib also blocks the tyrosine kinase activity of the abnormal tyrosine kinase (cKit) that is found in gastrointestinal stromal tumors (GIST) and platelet derived growth factor (PDGF), which is commonly mutated in renal cell carcinoma. Nilotinib received approval for use in the United States in 2007 for treatment of Philadelphia chromosome-positive CML resistant to or intolerant of prior treatment that included imatinib. Indications were subsequently expanded to include newly diagnosed cases of CML in the chronic phase. Nilotinib is available in capsules of 150 and 200 mg under the brand name Tasigna. The recommended initial dose is 400 mg by mouth twice daily, with dose modification based upon tolerance. Side effects are common and include fatigue, diarrhea, anorexia, skin discoloration, rash, hand-foot syndrome, edema, muscle cramps, arthralgias, headache, abdominal discomfort, anemia, cough and pruritus. Uncommon side effects include QT interval prolongation, heart failure, pancreatitis, tumor lysis syndrome and renal failure.

### Hepatotoxicity

Elevations in serum aminotransferase levels are common during nilotinib therapy, occurring in up to 70% of patients, but rising to greater than 5 times the upper limit of normal (ULN) in only 4% to 9% of recipients. These abnormalities are usually asymptomatic. If levels are markedly elevated (ALT or AST persistently greater than 5 times ULN or bilirubin more than 3 times ULN), dose adjustment or temporary discontinuation and restarting at a lower dose is recommended. In high doses, nilotinib is also associated with elevations in serum bilirubin, but these are largely in the indirect (unconjugated) fraction and are not associated with serum enzyme elevations or symptoms, resolving with dose adjustment or discontinuation. The majority of patients with marked bilirubin elevations on nilotinib therapy have underlying Gilbert Syndrome. There has been only a single published case report of clinically apparent liver injury attributed to nilotinib, but it has been used in a restricted population of patients for a relatively short period of time. The latency to onset was 2 months and the pattern of injury was hepatocellular initially, but evolved into a severe and prolonged cholestatic hepatitis. The product label does mention hepatitis and jaundice as reported adverse events. Severe tumor lysis syndrome with multiorgan including hepatic failure can occur with nilotinib but is rare. In addition, most other tyrosine kinase receptor inhibitors have been linked to rare instances of clinically apparent liver injury, usually arising after 1 to 8 weeks of treatment and presenting with a hepatocellular or mixed pattern of serum enzyme elevations. Immunoallergic and autoimmune features are uncommon. The liver injury can be severe and lead to acute liver failure. Routine monthly monitoring of liver tests during therapy with tyrosine kinase receptor inhibitors is recommended.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury due to nilotinib is unknown. Nilotinib is metabolized in the liver largely by the cytochrome P450 system, and liver injury may be due to accumulation of a toxic intermediate or from a drug-drug interaction with other medications.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Cross reactivity of the hepatic injury with other tyrosine kinase inhibitors is not common, but can occur. In using this medication, other potentially hepatotoxic agents should be avoided.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Drugs in the Subclass, Chronic Myeloid Leukemia Agents: Bosutinib, Dasatinib, Imatinib, Omacetaxine, Ponatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nilotinib – Tasigna®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nilotinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nilotinib | 641571-10-0 | C28-H22-F3-N7-O

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2020

Abbreviations: CML, chronic myelogenous leukemia.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556-7. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses gefitinib, erlotinib and crizotinib but not nilotinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Kantarjian H, Giles F, Wunderle L, Bhalla K, O'Brien S, Wassmann B, Tanaka C, et al. (2006). Nilotinib in imatinib-resistant CML and Philadelphia chromosome-positive ALL. N Engl J Med. (Trial of escalating doses of nilotinib in 119 patients with imatinib resistant chronic myelogenous leukemia [CML]; dose limiting toxic effects included elevations of indirect serum bilirubin [n=9] and ALT [n=3]; no mention of clinically apparent liver injury).
DeRemer DL, Ustun C, Natarajan K. (2008). Nilotinib: a second-generation tyrosine kinase inhibitor for the treatment of chronic myelogenous leukemia. Clin Ther. (Review of mechanism of action, pharmacology, clinical efficacy and tolerability of nilotinib based upon analyses of phase II and III trials; most common toxicities were neutropenia and thrombocytopenia, rash, nausea, headache, itching and fatigue. ALT and AST elevations were "infrequent", with values >5 times ULN in 1-4% of patients; instances of hyperbilirubinemia were also observed, but were self-limiting and attributed to Gilbert Syndrome).
Perini GF, Santos FP, Funke V, Ruiz J, Neto BH, Hamerschlak N. (2009). Nilotinib post-liver transplantation for acute hepatic failure related to imatinib. Leuk Res. (47 year old woman with CML developed jaundice and confusion after 18 months of imatinib therapy [bilirubin 20 mg/dL, ALT 828 U/L, prothrombin time 24 sec], leading to emergency liver transplantation; later treated with nilotinib without recurrence of liver injury).
Breccia M, Alimena G. (2009). Nilotinib therapy in chronic myelogenous leukemia: the strength of high selectivity on BCR/ABL. Curr Drug Targets. (Review of development, mechanism of action, clinical efficacy and safety of nilotinib, a tyrosine kinase receptor inhibitor similar to imatinib; serum bilirubin elevations occurred in 3-16% of patients; no mention of clinically apparent liver injury).
Koren-Michowitz M, le Coutre P, Duyster J, Scheid C, Panayiotidis P, Prejzner W, Rowe JM, et al. (2010). Activity and tolerability of nilotinib: a retrospective multicenter analysis of chronic myeloid leukemia patients who are imatinib resistant or intolerant. Cancer. (88 patients with CML who were intolerant or resistant to imatinib were treated with nilotinib for up to 3 years; 14% developed ALT or Alk P elevations, but none had clinically apparent liver injury, and 5 patients who stopped imatinib because of hepatotoxicity tolerated nilotinib without recurrence).
Saglio G, Kim DW, Issaragrisil S, le Coutre P, Etienne G, Lobo C, Pasquini R, et al. (2010). ENESTnd Investigators. Nilotinib versus imatinib for newly diagnosed chronic myeloid leukemia. N Engl J Med. (Controlled trial of 2 doses of nilotinib vs imatinib in 846 patients with CML found ALT elevations were more frequent with nilotinib than imatinib [66% and 73% vs 20% for any elevation, 4% and 9% vs 2% for elevations >5 times ULN]; hepatobiliary adverse events occurred in 4 nilotinib [0.7%] and in 1 imatinib [0.4%] recipient; details not given).
Martínez Pascual C, Valdés Mas M, de la Peña Moral JM, Miras López M. (2011). Med Clin (Barc). (34 year old woman with CML developed jaundice 8 months after starting imatinib [bilirubin 14.5 mg/dL, ALT 1856 U/L, Alk P 254 U/L], progressing to liver failure and liver transplantation).
Spataro V. (2011). Nilotinib in a patient with postnecrotic liver cirrhosis related to imatinib. J Clin Oncol. (41 year old woman with CML developed jaundice 6 months after starting imatinib [bilirubin 9.6 mg/dL, ALT 1374 U/L, Alk P 163 U/L, prothrombin index 27%, biopsy showing massive necrosis], recovering slowly with residual evidence of portal hypertension and subsequent biopsy showing cirrhosis; started on nilotinib for relapse in CML without worsening of liver tests).
Kantarjian HM, Hochhaus A, Saglio G, De Souza C, Flinn IW, Stenke L, Goh YT, et al. (2011). Nilotinib versus imatinib for the treatment of patients with newly diagnosed chronic phase, Philadelphia chromosome-positive, chronic myeloid leukaemia: 24-month minimum follow-up of the phase 3 randomised ENESTnd trial. Lancet Oncol. (Controlled trial of 2 doses of nilotinib vs imatinib for at least 24 months in 846 patients with CML found ALT elevations above 5 times ULN in 4% and 9% of patients on nilotinib vs 3% on imatinib; one patient on nilotinib had a "liver disorder", but no details given).
Usuki K, Tojo A, Maeda Y, Kobayashi Y, Matsuda A, Ohyashiki K, Nakaseko C, et al. (2012). Efficacy and safety of nilotinib in Japanese patients with imatinib-resistant or -intolerant Ph+ CML or relapsed/refractory Ph+ ALL: a 36-month analysis of a phase I and II study. Int J Hematol. (Among 34 Japanese patients with CML treated with nilotinib for 36 months, bilirubin elevations occurred in 29% and ALT elevations in 24%, but ALT above 5 times ULN in only 3% [1 patient]).
Nicolini FE, Masszi T, Shen Z, Gallagher NJ, Jootar S, Powell BL, Dorlhiac-Llacer PE, et al. (2012). Expanding Nilotinib Access in Clinical Trials (ENACT), an open-label multicenter study of oral nilotinib in adult patients with imatinib-resistant or -intolerant chronic myeloid leukemia in accelerated phase or blast crisis. Leuk Lymphoma. (Among 371 patients with CML in accelerated phase or blast crisis treated with nilotinib for up to 2 years found ALT elevations in 8% of patients, but levels above 5 times ULN in only 0.5% [2 patients]; serum bilirubin levels were elevated in 23%).
Larson RA, Hochhaus A, Hughes TP, Clark RE, Etienne G, Kim DW, Flinn IW, et al. (2012). Nilotinib vs imatinib in patients with newly diagnosed Philadelphia chromosome-positive chronic myeloid leukemia in chronic phase: ENESTnd 3-year follow-up. Leukemia. (Further follow up to 3 years of the patients with CML described by Kantarjian [2011] reported ALT elevations above 5 times ULN in 4.3% and 9.4% of nilotinib- vs 2.5% of imatinib-treated subjects).
Hua J, Iwaki Y, Inoue M, Hagihara M. (2013). Tumor lysis syndrome soon after treatment with hydroxyurea followed by nilotinib in two patients with chronic-phase chronic myelogenous leukemia. Int J Hematol. (44 year old man with CML in chronic phase developed metabolic acidosis within 10 hours of starting nilotinib [pH 6.9, creatinine 1.4 mg/dL, ALT 26 U/L] and rapidly decreasing white blood cell count [162,000 to 61,000/uL], followed by multiorgan and hepatic failure [bilirubin 4.4 mg/dL, ALT 1031 U/L], autopsy showing massive necrosis).
Engel T, Justo D, Amitai M, Volchek Y, Mayan H. (2013). Nilotinib-associated acute pancreatitis. Ann Pharmacother. (69 year old woman with CML developed abdominal pain within a day of starting nilotinib and was admitted with pancreatitis 6 days later [bilirubin 1.7 mg/dL, ALT normal, lipase 308 U/L], resolving on stopping and not recurring when switched to imatinib).
Lai GM, Yan SL, Chang CS, Tsai CY. (2013). Hepatitis B reactivation in chronic myeloid leukemia patients receiving tyrosine kinase inhibitor. World J Gastroenterol. (3 patients with CML and HBsAg carrier state were treated with imatinib [one had been switched to nilotinib] and developed reactivation of hepatitis B 6, 53 and 15 months later [bilirubin normal, 2.7 and 2.5 mg/dL, ALT 1086, 374 and 592 U/L, HBV DNA 229, 13 and 27 million IU/mL]; all three responded to entecavir therapy and were continued on the tyrosine kinase inhibitor).
Hughes TP, Hochhaus A, Kantarjian HM, Cervantes F, Guilhot F, Niederwieser D, le Coutre PD, et al. (2014). Safety and efficacy of switching to nilotinib 400 mg twice daily for patients with chronic myeloid leukemia in chronic phase with suboptimal response or failure on front-line imatinib or nilotinib 300 mg twice daily. Haematologica. (Among 283 patients with CML who were treated with imatinib [400 mg once daily] in a controlled trial [Kantarjian 2011], 57 discontinued therapy because of a suboptimal response, 35 of whom were switched to nilotinib [400 mg twice daily] in whom adverse events included rash [29%], headache [23%] and ALT elevations [74%], all of which except one were less than 5 times ULN, and no patient stopped therapy because of liver test abnormalities).
Hochhaus A, Saglio G, Hughes TP, Larson RA, Kim DW, Issaragrisil S, le Coutre PD, et al. (2016). Long-term benefits and risks of frontline nilotinib vs imatinib for chronic myeloid leukemia in chronic phase: 5-year update of the randomized ENESTnd trial. Leukemia. (Among 846 adults with CML in chronic phase treated with imatinib or nilotinib in a controlled trial, 5 year follow up was available on 50-60% of patients in whom the rate of ALT elevations above 5 times ULN on nilotinib was 4.3% [300 mg twice daily] and 9.4% [400 mg twice daily], and none of the 50 deaths were attributed to liver failure, only half being due to progression of disease).
Hiwase D, Tan P, D'Rozario J, Taper J, Powell A, Irving I, Wright M, et al. (2018). Efficacy and safety of nilotinib 300 mg twice daily in patients with chronic myeloid leukemia in chronic phase who are intolerant to prior tyrosine kinase inhibitors: Results from the Phase IIIb ENESTswift study. Leuk Res. (Among 20 patients with CML intolerant to first and second generation BCR-ABL1 inhibitors who were switched to nilotinib [300 mg twice daily], 10 achieved a deep molecular response by month 12 and there were no withdrawals because of adverse events; 2 patients [10% ] had transient ALT elevations, all were less than 5 times ULN, asymptomatic and without jaundice).
Kuo CY, Wang PN, Hwang WL, Tzeng CH, Bai LY, Tang JL, Chang MC, et al. (2018). Safety and efficacy of nilotinib in routine clinical practice in patients with chronic myeloid leukemia in chronic or accelerated phase with resistance or intolerance to imatinib: results from the NOVEL study. Ther Adv Hematol. (Among 85 patients with CML treated with nilotinib over a two year period in 12 Taiwanese centers, common drug related adverse events were thrombocytopenia [21%] and ALT elevations [21%], only 1 of which was greater than 5 times ULN).
Iurlo A, Bucelli C, Cattaneo D, Levati GV, Viani B, Tavazzi D, Consonni D, et al. (2019). UGT1A1 genotype does not affect tyrosine kinase inhibitors efficacy and safety in chronic myeloid leukemia. Am J Hematol. (Genotypes of the uridine-50-diphosphate glucuronosyltransferase [UGT]-1A1 gene in 105 patients with CML treated with various tyrosine kinase inhibitors found no correlation of homozygosity of 7*/7* [TA7TAA] and either efficacy [progression-free survival] or hematologic or extra-hematologic adverse event rates except for hyperbilirubinemia which occurred in 15 of 17 patients with Gilbert syndrome).
García-Gutiérrez V, Hernández-Boluda JC. (2019). Tyrosine kinase inhibitors available for chronic myeloid leukemia: efficacy and safety. Front Oncol. (Review of current therapy of CML using first [imatinib], second [nilotinib, dasatinib, bosutinib], and third generation [ponatinib] tyrosine kinase inhibitors, posatinib being used only after failure of 1 or 2 other agents, its major shortcoming being high rate of adverse effects including major cardiovascular complications particularly with high doses of ponatinib; no discussion of hepatotoxicity).
Belopolsky Y, Grinblatt DL, Dunnenberger HM, Sabatini LM, Joseph NE, Fimmel CJ. (2019). A case of severe, nilotinib-induced liver injury. ACG Case Rep J. (53 year old woman with CML developed fever and leg pains soon after starting imatinib with mild increases in ALT and Alk P, improving on stopping but then developing jaundice 2 months after initiating nilotinib therapy [bilirubin ~ 10 rising to 35 mg/dL, ALT 2000 U/L, Alk P not given, biopsy showing severe cholestatic hepatitis], with prolonged jaundice and incomplete resolution when seen 6 months later [bilirubin 1.5 mg/dL, ALT 47 U/L, Alk P 175 U/L]).
Lopina N, Dmytrenko I, Hamov D, Lopin D, Dyagil I. (2019). Novel score-based decision approach in chronic myeloid leukemia patients after acute toxic imatinib-induced liver injury. Cureus. (Discussion of factors in deciding whether to restart tyrosine kinase inhibitors in patients with CML who develop liver test abnormalities during therapy, five major factors being [1] the severity of the liver injury, [2] the presence of cirrhosis or a liver transplant, [3] the degree of response to the kinase inhibitor, [4] whether other drugs may have contributed, and [5] the presence of hepatitis virus infection and risk of reactivation).

## OTHER REFERENCE LINKS

1 Recent References on Nilotinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nilotinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nilotinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nilotinib)